# Celecoxib

## OVERVIEW

### Introduction

Celecoxib is a nonsteroidal antiinflammatory drug (NSAID) with selectively for inhibition of cyclooxygenase-2 (Cox-2), which is widely used in the therapy of arthritis. Celecoxib has been linked to rare instances of idiosyncratic drug induced liver disease.

### Background

Celecoxib (sel" e kox' ib) is a commonly used NSAID with relative specificity for Cox-2 compared to Cox-1. Like other NSAIDs, celecoxib acts by inhibition of prostaglandin synthesis thereby decreasing mediators of inflammation, fever and pain. The specificity for Cox-2 is believed to make celecoxib less likely to cause gastrointestinal mucosal injury compared to standard NSAIDs that inhibit both Cox-1 and Cox-2 enzymes. Celecoxib is indicated for therapy of chronic arthritis due to osteoarthritis, rheumatoid arthritis, juvenile rheumatoid arthritis and ankylosing spondylitis. It is also approved for use in acute pain from musculoskeletal conditions and trauma and for primary dysmenorrheal. Because of the role of the Cox-2 enzyme system in the growth of adenomatous polyps, celecoxib is also used to prevent adenomatous polyp formation in persons at high risk. Celecoxib was first approved for use in the United States in 2000 and became the only Cox-2 specific NSAID available when rofecoxib was withdrawn in 2006 because of increased rate of cardiovascular events associated with its long term use. Celecoxib is available by prescription as capsules of 50, 100, 200 and 400 mg generically and under the commercial name Celebrex and is usually given in several week courses or long term. The recommended dose varies by indication, the usual adult dose in arthritis being 100 to 200 mg twice daily. Currently there are more than 6 million prescriptions filled for celecoxib yearly for more than 2 million patients in the United States. Like most NSAIDs, celecoxib is generally well tolerated, but side effects can include dizziness, headache, somnolence, rash, nausea, diarrhea, abdominal discomfort, heartburn, peripheral edema, infertility, fetal toxicity, and hypersensitivity reactions. Rare but potentially serious adverse events from NSAIDs such as celecoxib include gastrointestinal ulceration, bleeding, and perforation, an increased risk for serious cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, infertility, and acute hypersensitivity reactions including anaphylaxis, exfoliative dermatitis, DRESS syndrome, and Stevens Johnson syndrome.

### Hepatotoxicity

In clinical studies involving several thousand patients treated for at least 3 months, the rate of serum aminotransferase enzyme elevations above three times the upper limit of the normal range was 1.1% in celecoxib treated compared to 0.9% in placebo treated patients. The ALT elevations that occurred during celecoxib therapy were usually transient and benign, resolving even with continuation of the medication. It is unclear whether such elevations are due to the medication since similar rates of abnormalities are identified in patients with arthritis receiving placebo.

In rare instances, celecoxib appears to cause clinically apparent, symptomatic and icteric drug induced liver injury. In reported cases, the pattern of liver enzyme elevations has ranged from hepatocellular (Case 1) to cholestatic (Case 2). Moreover, the resulting jaundice can be prolonged and accompanied by severe pruritus and chronic fatigue (Case 3). The latency to onset of liver injury is often short, and the abruptness of onset resembles the hepatotoxicity caused by the sulfonamides. Indeed, in several instances, patients with celecoxib hepatotoxicity have a past history of sulfonamide hypersensitivity. Furthermore, celecoxib liver injury may occur in patients who have been treated with the drug without incident in the past, and reexposure after celecoxib liver injury usually results in reoccurrence with shortening of the latency period. Immunoallergic features are not uncommon in patients with clinically apparent liver injury due to celecoxib, but they are rarely prominent. Autoimmune markers and features of autoimmunity are not common, although they may be present because of the underlying disease for which the celecoxib is prescribed. The frequency of clinically apparent liver injury from celecoxib use is estimated to be between 1:14,000 to 1:25,000 users. Rare complications of celecoxib induced liver injury include prolonged cholestatic hepatitis, vanishing bile duct syndrome, and Stevens Johnson syndrome.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The acute hepatic injury from celecoxib resembles that of the sulfonamides and a history of sulfa-allergy is common. These features of celecoxib hepatotoxicity suggest an immune and allergic-hypersensitivity etiology.

### Outcome and Management

The idiosyncratic liver injury due to celecoxib can lead to prolonged jaundice and to a vanishing bile duct syndrome that can be severe and lead to hepatic failure and need for liver transplantation. Cases of acute liver failure with massive necrosis have not been specifically linked to celecoxib therapy in the published literature, although the possibility of liver failure is mentioned in the product labeling. In the few cases of self-limited liver injury that have been described, the time to recovery has varied greatly, from a few weeks to more than a year. Rechallenge should be avoided and patients should also be told to avoid sulfa-containing medications. Corticosteroids have been used to treat the immunoallergic features of celecoxib hypersensitivity, but their role in decreasing liver injury or improving outcome has not been shown (Cases 2 and 3).

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORTS

### Case 1. Acute hepatocellular injury with jaundice due to celecoxib.(1)

A 67 year old woman with osteoarthritis was treated with celecoxib (100 mg twice daily) for one week during which she developed abdominal pain and jaundice. She was hospitalized and celecoxib was stopped. She had multiple other medical problems including hypertension, diabetes, coronary artery disease, congestive heart failure, peptic ulcer disease and osteoarthritis and had been taking several medications in constant doses for some time. On admission, she had fever but no rash. Her jaundice deepened for a day, but then improved rapidly. Tests for hepatitis A, B and C and for autoantibodies were negative. Ultrasound of the abdomen was normal. A liver biopsy was not done.

#### Key Points

Medication: | Celecoxib
Pattern: | Hepatocellular (R=13.8)
Severity: | 3+ (symptoms, jaundice and hospitalization)
Latency: | <1 week
Recovery: | Complete within 2 weeks of onset
Other medications: | Enalapril, metoprolol, isosorbide mononitrate, furosemide, iron, vitamin C

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin* (mg/dL) | Other
Pre | | 14 | 76 | 0.7
Celecoxib Stopped after 7 Days
1 week | 0 | 603 | 150 | 4.9 | INR=1.02, albumin 3.4 g/dL
| 1 day | 305 | 161 | 7.5
2 weeks | 1 week | 23 | 146 | 1.9
3 weeks | 2 weeks | 27 | 100 | 0.9
Normal Values | | <35 | <120 | <1.2

* Converted from µmol/L.

#### Comment

The history and presentation of this case were typical of an immuno-allergic acute hepatitis from a medication and the only new medication that she was receiving was celecoxib. Once celecoxib was stopped, recovery was rapid. There was no mention of eosinophilia or history of allergy to sulfonamides.

### Case 2. Severe cholestatic hepatitis and liver failure due to celecoxib.(2)

A 52 year old woman developed fatigue, pruritus and dark urine three days after starting celecoxib (200 mg, 2 to 3 times daily) for minor muscle aches. She stopped the medication (after 8 tablets), but had worsening symptoms and jaundice. One week after stopping she sought medical advice. She was a registered nurse, but had no previous history of liver disease and was known to have normal serum enzymes and to lack markers of hepatitis B, C and HIV infection. She did not drink alcohol, took no other medications or over-the-counter preparations, and denied exposures to viral hepatitis, history of drug-reactions, or specific risk factors other than nursing occupation. On examination, she was jaundiced and the liver was tender, but she had no fever or there was no mention of rash. Laboratory results showed eosinophilia (760 cells/uL) and elevated bilirubin and alkaline phosphatase levels (Table). Tests for hepatitis A, B and C were negative as were autoantibody markers. An abdominal CT scan showed no evidence of biliary tract obstruction. A liver biopsy showed cholestasis, loss of bile ducts ("ductopenia") and minimal periportal fibrosis. Over the next few weeks, her symptoms worsened and jaundice deepened. She was treated with ursodiol (500 mg twice daily) and then prednisone (40 mg daily), but bilirubin rose to 35 mg/dL and renal insufficiency developed. She had signs of progressive hepatic failure and underwent liver transplantation 54 days after the initial dose of celecoxib. The explant showed marked cholestasis and prominent ductopenia, but no cirrhosis. In follow up after transplant, her liver tests fell to normal.

#### Key Points

Medication: | Celecoxib
Pattern: | Cholestatic (R=0.6)
Severity: | 5+ (liver transplantation)
Latency: | 3 days to onset of symptoms
Recovery: | None
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | INR
Pre | | 18 | 78 | 0.4 | 1.0
Celecoxib taken for three days
10 days | 1 week | 258 | 700 | 10.8 | 1.0
24 days | 3 weeks | 297 | 889 | 15.0 | 1.0
2 months | 7 weeks | 167 | 1024 | 38.0 | 2.6
Orthotopic Liver Transplantation on day 54 after starting celecoxib
6 months after transplant | | 27 | 100 | 0.9 | 1.1
Normal Values | | <72 | <126

#### Comment

A dramatic example of severe immuno-allergic liver injury with acute cholestasis and rapid progression to vanishing bile duct syndrome and hepatic failure. Celecoxib has been linked to several instances of vanishing bile duct syndrome, but the course of injury is usually much more prolonged and can ultimately resolve.

### Case 3. Prolonged mixed injury with cholestasis due to celecoxib.(3)

A 38 year old woman with chronic back pain after a motor vehicle accident was treated with celecoxib (100 mg twice daily) for several weeks without incident and again six months later for persistence of the pain. During the second course of celecoxib, she stopped the medication after 23 days when she developed nausea and right upper abdominal pain. During the next few days she developed jaundice and pruritus and was hospitalized. She reported no other medical problems and was taking no medications except for occasional aspirin and acetaminophen for her back pains. She had no history of alcohol abuse, allergies or drug reactions. On admission, she was mildly jaundiced, but had no rash or fever. There were moderate elevations in serum aminotransferase and alkaline phosphatase levels (Table). The white blood cell count was normal without eosinophilia. Tests for hepatitis A, B and C and for autoantibodies were negative. Ultrasound and MRI of the liver and abdomen were normal without evidence of biliary obstruction. She improved very slowly and because of persistence of jaundice, a liver biopsy was done that showed intrahepatic cholestasis compatible with acute drug induced liver injury. She was treated with a short course of prednisone with no little improvement in liver tests. Serum bilirubin eventually fell into the normal range, she continued to complain of nausea and fatigue and had persistence of cholestatic liver enzyme elevations more than six months after onset.

#### Key Points

Medication: | Celecoxib
Pattern: | Initially hepatocellular (R=8.4), later mixed (R=5.7→2.8)
Severity: | 3+ (symptoms, jaundice and hospitalization)
Latency: | 3 weeks
Recovery: | Complete within 4 months of onset
Other medications: | Rarely aspirin, acetaminophen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Celecoxib taken for 21 Days
27 days | 4 days | 687 | 304 | 3.7 | Albumin 4.6
28 days | 5 days | 476 | 243 | 3.9 | INR 1.0
31 days | 8 days | 399 | 264 | 4.2
5 weeks | 12 days | 312 | 369 | 4.9 | Liver biopsy
10 weeks | 47 days | 310 | 400 | 2.4
20 weeks | 17 weeks | 260 | 700 | 1.4
6 months | 5 months | 87 | 518 | 1.0
9 months | 8 months | 122 | 588 | 1.0
Normal Values | | <35 | <120

#### Comment

Despite the rarity of drug induced liver injury from celecoxib, this case was convincing in that there was a sudden onset of a cholestatic and prolonged hepatitis after 3 weeks of celecoxib. No other medications were being taken and no other cause for liver disease was identified. Serum enzyme elevations were initially in the hepatocellular range, but soon became distinctly cholestatic. Recovery was prolonged and incomplete. She likely has mild or partial form of vanishing bile duct syndrome, not enough to cause persistent jaundice, but enough to cause symptoms and chronic serum alkaline phosphatase elevations.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Celecoxib – Celebrex®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=celecoxib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Celecoxib | 184007-95-2 | C17-H14-F3-N3-O2-S

## CITED REFERENCES

1 Nachimuthu S, Volfinzon L, Gopal L. Acute hepatocellular and cholestatic injury in a patient taking celecoxib. Postgrad Med J 2001; 77: 548-50.11470953
2 El Hajj, Malik SM, Alwakeel HR, Shaikh OS, Sasatomi E, Kandil HM. Celecoxib-induced cholestatic liver failure requiring orthotopic liver transplantation. World J Gastroenterol 2009; 15: 3937-9.19701976
3 Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9.26601797

## ANNOTATED BIBLIOGRAPHY

References updated: 17 September 2025

Abbreviations used: NSAID, nonsteroidal anti-inflammatory drug; COX-1 and -2, cyclo-oxygenase 1 and 2; DRESS, drug reaction with eosinophilia and systemic symptoms; VBDS, vanishing bile duct syndrome.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd edition. Philadelphia: Lippincott Williams & Wilkins, 1999. p.517-541. (Expert review of non-steroidal anti-inflammatory drug (NSAID) induced liver injury from 1999, before availability of celecoxib).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd. Amsterdam: Elsevier, 2013, pp. 369-401. (Review of hepatotoxicity of NSAIDs mentions that celecoxib that cause acute cholestatic hepatitis which is usually reversible).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics; celecoxib is the only selective cyclooxygenase-2 [Cox-2] inhibitor licensed for use in the U.S.; the selectivity of celecoxib for Cox-2 vs Cox-1 is relative, and in vitro, the selectivity of celecoxib is close to that of meloxicam and diclofenac).
McCormick PA, Kennedy F, Curry M, Traynor O. COX 2 inhibitor and fulminant hepatic failure. Lancet 1999; 353: 40-1. (58 year old woman developed symptoms after 2 weeks and jaundice after 7 weeks of nimesulide, a Cox-2 inhibitor that was licensed in Europe but not in the US. ALT levels rose from 187 to 2857 U/L, Alk P from 50 to 114 U/L, and bilirubin to 6.5 mg/L; native liver showed massive necrosis at time of liver transplantation and patient died of primary non-function). 10023957
Carrillo-Jimenez R, Nurnberger M. Celecoxib-induced acute pancreatitis and hepatitis: a case report. Arch Intern Med 2000; 160: 553-4. PMID: (84 year old man with a history of sulfa-allergy developed acute pancreatitis 2 days after starting celecoxib [ALT 210 U/L, no jaundice], resolving rapidly). 10695699
Maddrey WC, Maurath CJ, Verburg KM, Geis GS. The hepatic safety and tolerability of the novel cyclooxygenase-2 inhibitor celecoxib. Am J Ther 2000; 7: 153-8. (Combined analyses of 14 controlled trials of celecoxib: ALT elevations >3 times ULN occurred in 0.4% of 6376 patients on celecoxib compared to 0.5% of 1864 on placebo, 0.4% of 1366 on naproxen, 0% of 345 on ibuprofen and 2.1% of 1057 on diclofenac; none developed clinically apparent liver injury). 11317164
Whelton A. COX-1 sparing and COX-2 inhibitory drugs: the renal and hepatic safety and tolerability profiles of celecoxib. Am J Ther 2000; 7: 151-2. (Editorial in response to article by Maddrey et al). 11317163
Silverstein FE, Faich G, Goldstein JL, Simon LS, Pincus T, Whelton A, Makuch R, et al. Gastrointestinal toxicity with celecoxib vs nonsteroidal anti-inflammatory drugs for osteoarthritis and rheumatoid arthritis: the CLASS study: A randomized controlled trial. Celecoxib Long-term Arthritis Safety Study. JAMA 2000; 284: 1247-55. (Controlled trial of celecoxib [3987] vs ibuprofen [1985] or diclofenac [1996]: rates of ulcer complications [0.7% vs 1.4% per year] and ALT elevations [0.5% vs 1.8% in first 6 months] were lower in patients on celecoxib vs standard NSAIDs). 10979111
Galan MV, Gordon SC, Silverman AL. Celecoxib-induced cholestatic hepatitis. Ann Intern Med 2001; 134: 254. (55 year old woman developed rash, jaundice and eosinophilia 3 weeks after starting celecoxib [bilirubin 12.2 mg/dL, ALT 264 U/L, Alk P 283 U/L] with prolonged cholestasis but resolving 4 months after stopping). 11177350
Nachimuthu S, Volfinzon L, Gopal L. Acute hepatocellular and cholestatic injury in a patient taking celecoxib. Postgrad Med J 2001; 77: 548-50. (67 year old woman developed pain, fever and jaundice 1 week after starting celecoxib [bilirubin 4.9 mg/dL, ALT 603 U/L, Alk P 150 U/L], resolving within 2 weeks of stopping: Case 1). 11470953
O'Beirne JP, Cairns SR. Drug Points: cholestatic hepatitis in association with celecoxib. BMJ 2001; 323: 23. (54 year old woman developed jaundice and eosinophilia a few days after restarting celecoxib [bilirubin 7.2 mg/dL, ALT 1650 U/L, Alk P 232 U/L], resolving within 4 weeks). 11440939
Mohammed F, Smith AD. Cholestatic hepatitis in association with celecoxib. Classification of drug associated liver dysfunction is questionable. BMJ 2002; 325: 220; author reply 220. (Letter in response to O’Beirne article suggesting that the injury was hepatocellular rather than cholestatic). 12142317
Arellano FM, Zhao SZ, Reynolds MW. Case of cholestatic hepatitis with celecoxib did not fulfil international criteria. BMJ 2002; 324: 789. (Letter in response to O’Beirne). 11923170
Alegria P, Lebre L, Chagas C. Celecoxib-induced cholestatic hepatotoxicity in a patient with cirrhosis. Ann Intern Med 2002; 137: 75. (49 year old man with alcoholic cirrhosis developed jaundice 15 days after starting celecoxib [bilirubin 31.6 mg/dL, ALT 49 U/L, Alk P 205 U/L]; reversing only after ~12 months). 12093262
Grieco A, Miele L, Giorgi A, Civello IM, Gasbarrini G. Acute cholestatic hepatitis associated with celecoxib. Ann Pharmacother 2002; 36: 1887-9. (41 year old man developed jaundice after 2 doses of celecoxib [bilirubin rising to 17.4 mg/dL, ALT 97 U/L, Alk P 302 U/L, no eosinophilia]; resolving in 3 weeks). 12452750
Waldum HL. Comment: acute cholestatic hepatitis associated with celecoxib. Ann Pharmacother 2003; 37: 748; author reply 748-9. (Letter suggesting that liver injury described by Grieco [2002] was due to Sphincter of Oddi spasm with reply from authors suggesting not). 12708959
Fradet G, Robin-Le Nechet A, Huguenin H, Chiffoleau A. [Hypersensitivity to celecoxib.] Ann Med Interne (Paris) 2003; 154: 181-2. French. PMID: 12910047 (69 year old woman developed fever, rash, and facial edema 11 days after starting celecoxib and acetaminophen with dextropropoxyphene for lower back pain [bilirubin not provided, ALT 276 U/L, Alk P 221 U/L, eosinophils 1,128/μL], DRESS syndrome and liver tests resolving within a few weeks of discontinuation).
Zinsser P, Meyer-Wyss B, Rich P. Hepatotoxicity induced by celecoxib and amlodipine. Swiss Med Wkly 2004; 134: 201. (Patient developed hepatitis after 2 years of intermittent celecoxib therapy [bilirubin ~8 mg/dL, ALT 1058 U/L, Alk P 1102 U/L]; clinical recovery within 2 months of stopping but biochemical abnormalities persisted for a year). 15106034
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug-induced liver failure; 1 was attributed to bromfenac, 1 to naproxen, but none to celecoxib or other NSAIDs) 15390328
Campbell MS, Makar GA. Safety of short-term administration of celecoxib in decompensated cirrhosis. Hepatology 2005; 42: 237; author reply 238. PMID: (Criticism of previous report on renal function in cirrhosis and celecoxib). 15892075
Chamouard P, Walter P, Baumann R, Poupon R. Prolonged cholestasis associated with short-term use of celecoxib. Gastroenterol Clin Biol 2005; 29: 1286-8. 2 year old woman developed jaundice and pruritus 3 weeks after starting a 12 day course of celecoxib [bilirubin 20 mg/dL, ALT 69 U/L, Alk P 613 U/L]; jaundice required 3 months to resolve, pruritus disappearing only after 18 months). 16518289
Ogunlade SO, Oginni LM, Nwadiaro HC, et al. The efficacy and toleration of celecoxib (Celebrex) in the treatment of osteoarthritis in Nigeria: a multicentre study. West Afr J Med 2005; 24: 263-7. (Trial of celecoxib in 80 patients with osteoarthritis: no hepatic changes noted during 6 weeks of therapy). 16276709
Rostom A, Goldkind L, Laine L. Nonsteroidal anti-inflammatory drugs and hepatic toxicity: a systematic review of randomized controlled trials in arthritis patients. Clin Gastroenterol Hepatol 2005; 3: 489-98. (Systematic review of trials reporting side effects from different NSAIDs: found rate of ALT elevations >3 fold elevated to be 0.4% among 12,750 celecoxib-treated persons, which was similar to that in placebo recipients [0.3%]; no episodes of clinically apparent hepatitis). 15880319
Lapeyre-Mestre M, de Castro AM, Bareille MP, Garcia del Pozo J, Requejo AA, Arias LM, Montastruc J-L, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20: 391-5. (Study comparing rates of spontaneous reporting of adverse events to use of different NSAIDs in Spain and France found high rate of liver reports [compared to all types] for sulindac and nimesulide, low for celecoxib: 6 cases of hepatotoxicity attributed to celecoxib from Spain and 6 from France between 1982 and 2001). 16867024
Sanchez-Matienzo D, Arana A, Castellsague J, Perez-Gutthann S. Hepatic disorders in patients treated with COX-2 selective inhibitors or nonselective NSAIDs: a case/noncase analysis of spontaneous reports. Clin Ther 2006; 28: 1123-32. (Review of FDA Medwatch reports of adverse events: 158,539 received, 3% liver-related; higher proportion liver adverse events for sulindac, diclofenac and nimesulide; not for other Cox-2 inhibitors including celecoxib). 16982289
Tabibian JH, Tabibian N, Kaufman DM. Late-onset celecoxib-induced combined hepato-nephrotoxicity. BJCP 2008; 66: 150-1. (56 year old man developed fatigue and abdominal pain followed by jaundice, 10 months after starting celecoxib, [bilirubin 32.4 mg/dL, creatinine 5.2 mg/dL, ALT and Alk P normal] with biopsy showing liver injury; improving on stopping therapy). 18325075
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug-induced liver disease in the U.S. collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam, 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]). 18955056
Soni P, Shell B, Cawkwell G. The hepatic safety and tolerability of the cyclooxygenase-2 selective NSAID celecoxib: pooled analysis of 41 randomized controlled trials. Curr Med Res Opin 2009; 25: 1841-51. (Retrospective analysis of 41 controlled trials of celecoxib vs placebo or other NSAIDS; found ALT elevations > 5 times ULN similar in celecoxib (1.1%) as placebo-treated (0.9%) and lower than with diclofenac (4.2%); no clinically apparent hepatitis among 24,933 celecoxib recipients). 19530981
El Hajj, Malik SM, Alwakeel HR, Shaikh OS, Sasatomi E, Kandil HM. Celecoxib-induced cholestatic liver failure requiring orthotopic liver transplantation. World J Gastroenterol 2009; 15: 3937-9. PMID: (52 year old woman developed fatigue, pruritus and dark urine 3 days after starting celecoxib [bilirubin 10.8 mg/dL, ALT 258 U/L, Alk P 700 U/L]; progressing to hepatic failure and need for liver transplant 51 days later: Case 2). 19701976
Lee CH, Wang JD, Chen PC. Increased risk of hospitalization for acute hepatitis in patients with previous exposure to NSAIDs. Pharmacoepidemiol Drug Saf 2010; 19: 808-14. (Analysis of Taiwan National Health Insurance database for association of NSAID use with toxic hepatitis found increased odds of recent use of celecoxib [Odds Ratio=1.92], nimesulide [2.63], diclofenac [2.22], and ibuprofen [2.51]). 20572024
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug-induced liver injury of which 7 were due to NSAIDs, including 4 attributed to bromfenac, 2 to diclofenac and 1 to etodolac, but none to celecoxib). 20949552
Famularo G, Gasbarrone L, Minisola G. Probable celecoxib-induced hepatorenal syndrome. Ann Pharmacother 2012; 46: 610-1.. (77 year old woman developed fever and fatigue 12 days after starting celecoxib for gout [bilirubin 2.4 mg/dL, ALT 398 U/L, Alk P 696 U/L, INR 5.0 on warfarin, creatinine 3.0 mg/dL] resolving within 1 week of stopping: renal abnormalities likely due to dehydration rather than hepatorenal syndrome). 22474138
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. (Analysis of cases of idiopathic acute liver failure undergoing liver transplantation in 52 centers in Europe between 2005 and 2007, found 40 had been exposed to an NSAID [14 to ibuprofen, 8 to nimesulide, 6 to diclofenac, and 2 to naproxen and celecoxib] within the previous 30 days with estimated event rates of 2.2 per million treatment-years for celecoxib). 23325533
Lapeyre-Mestre M, Grolleau S, Montastruc JL; Adsociation Française des Centres Régionaux de Pharmacovigilance (CRPV). Adverse drug reactions associated with the use of NSAIDs: a case/noncase analysis of spontaneous reports from the French pharmacovigilance database 2002-2006. Fundam Clin Pharmacol 2013; 27: 223-30. (Analysis of 42,389 spontaneous serious adverse event reports to the French Pharmacovigilance database on 8 NSAIDs between 2002 and 2006; liver adverse events were most frequent with nimesulide [0.15 per million daily doses] compared to diclofenac [0.09], ketoprofen [0.09] piroxicam [0.06], naproxen [0.04], meloxicam [0.03], and tenoxicam [0.03]; celecoxib not discussed). 21929527
Nayudu SK, Badipatla S, Niazi M, Balar B. Cholestatic hepatitis with small duct injury associated with celecoxib. Case Rep Med 2013; 2013: 315479. (34 year old woman developed jaundice 3 weeks after starting celecoxib for menstrual pain [bilirubin 3.4 mg/dL, ALT 458 U/L, Alk P 231 U/L], resolving within 1 month of stopping). 23861685
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2-year period, including 6 attributed to diclofenac [ranking 2nd], but none due to celecoxib). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common class of implicated agents being NSAIDS [n=62, 32%], but specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]; celecoxib was not listed]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 3 cases [0.3%] were attributed to celecoxib, with latencies of 16, 23 and 145 days, hepatocellular or mixed enzyme elevations and self-limited course in 2 and prolonged cholestasis in one). 25754159
Ishiguro N, Hanaoka A, Okada T, Ito M. Efficacy and safety of celecoxib compared with placebo and etodolac for acute postoperative pain: a multicenter, double-blind, randomized, parallel-group, controlled trial. Nagoya J Med Sci. 2015;77(1-2):81-93.. (Among 616 patients with moderate to severe post-operative pain treated with celecoxib (initially 400 mg then 200 mg], etodolac [200 mg], or placebo twice daily for at least 2 days, pain control was achieved in 76% vs 68% vs 64%, adverse event rates were similar in the 3 groups, mild ALT elevations occurring in 0.8% vs 1.2% vs none, and there were no serious adverse events). 25797973
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, including 3 due to celecoxib: Case 3). 26601797
Tujios SR, Lee WM. Acute liver failure induced by idiosyncratic reaction to drugs: challenges in diagnosis and therapy. Liver Int 2018; 38: 6-14. (Review of acute liver failure and the contribution of drug induced liver injury, of which 5% were due to NSAIDs, most commonly diclofenac and etodolac). 28771932
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen and aspirin and that rare instances of idiosyncratic acute hepatitis attributed to celecoxib have been described). 29469052
Sriuttha P, Sirichanchuen B, Permsuwan U. Hepatotoxicity of nonsteroidal anti-inflammatory drugs: a systematic review of randomized controlled trials. Int J Hepatol. 2018;2018:5253623.. (Systematic review of randomized controlled trials of NSAIDs that reported monitoring for hepatoxicity identified 18 studies but only 3 NSAIDs showed an increase rates of liver injury with the drug compared to placebo, including diclofenac, celecoxib, and etoricoxib). 29568654
Mukthinuthalapati PK, Fontana RJ, Vuppalanchi R, Chalasani N, Ghabril M. celecoxib-induced liver injury: analysis of published case reports and cases reported to the Food and Drug Administration. J Clin Gastroenterol. 2018;52:114-122.. (Review of published reports of celecoxib-induced liver injury identified 18 cases, mean age 51 years, 17 women, mostly with symptoms and jaundice, hepatocellular in 40% and mixed or cholestatic in 60%, latency typically less than 8 weeks, outcome fatal in 2 and with chronic residual injury in 4; review of 100 FDA MedWatch reports on celecoxib liver injury found similar distribution of sex and age of subjects, and a mortality rate of 10%). 28795997
Larrey E, Patouraux S, Spreux A, Canivet CM, Piche T, Tran A, Anty R. Fatal cholestatic hepatitis after a single dose of celecoxib. Clin Res Hepatol Gastroenterol. 2019;43:e82-e85.. (74 year old woman developed nausea and fatigue a few hours after taking a single 200 mg dose of celecoxib, followed by transient fever and rash, and jaundice 4 days later [bilirubin 21 mg/dL, ALT 189 U/L, Alk P 1295 U/L, INR normal], followed by progressively worsening jaundice and refractory pruritus, a liver biopsy showing vanishing bile duct syndrome that led death from multiorgan failure 6 months after onset). 30449626
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40.. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Ma J, Björnsson ES, Chalasani N. The safe use of analgesics in patients with cirrhosis: a narrative review. Am J Med. 2024;137:99-106.. (Review of the safety of analgesic use in patients with cirrhosis, mentions that the dose of celecoxib should be reduced by 50% in patients with Child’s B cirrhosis and avoided in those with Child’s C cirrhosis). 37918778
Shionoya K, Kobayashi M, Kako M, Masuda S, Makazu M, Koizumi K. Drug-induced liver injury considered steroid-resistant and histologically diagnosed with vanishing bile duct syndrome. Intern Med. 2024;63:1719-1723.. (70 year old man developed fatigue followed by jaundice shortly after starting celecoxib [bilirubin 10 mg/dL, ALT 136 U/L, Alk P 1485 U/L, INR 1.2] that progressed to vanishing bile duct syndrome, hepatic failure and death within 6 weeks of onset). 37952956
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-update with genetic correlations. Liver Int. 2024;44:1409-1421.. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 7 were attributed to celecoxib including 4 women and 3 men, mean age 60 years, latency 31 days, with initial bilirubin 6.3 mg/dL, ALT 526 U/L, and Alk P 495 U/L). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib). 38913369
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 23 cases due to diclofenac for an estimated incidence of 1 per 4,800 new persons treated each year, while other NSAIDs had lower numbers and estimated rates, including celecoxib [4, 1:25,000] and meloxicam [n=3, 1:87,000], incidence rates for ibuprofen and naproxen could not be estimated because of lack of data on over-the-counter use). 39317916
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10-year period, 49 were attributed to NSAIDs, including 19 [4.1%] to diclofenac, 14 [3.0%] to nimesulide and 11 [2.4%] to ibuprofen, but only one for celecoxib, meloxicam, piroxicam, ketorolac, and ketoprofen). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Celecoxib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=celecoxib+AND+sulfonamides/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222008/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Celecoxib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=celecoxib)